# Nafcillin

## OVERVIEW

### Introduction

Nafcillin is a parenteral, second-generation penicillinase-resistant penicillin antibiotic used largely to treat moderate to severe staphylococcal infections. Nafcillin has been linked to rare occurrences of clinically apparent, idiosyncratic liver injury.

### Background

Nafcillin (naf sil' in) is a second-generation penicillin that is highly resistant to inactivation by penicillinases and is used to treat moderate-to-severe bacterial infections caused by penicillinase-producing bacteria. Nafcillin was approved for use in the United States in 1970 and is still widely used to treat severe staphylococcal infections. To reduce development of drug-resistant bacteria, nafcillin is recommended to treat or prevent only infections that are proven or suspected to be caused by penicillinase-producing susceptible bacteria. Nafcillin is available in multiple generic forms as solutions or powders for intravenous or intramuscular use in 1- or 2-gram vials. Oral formulations have been developed and are available in some countries. The recommended dose for parenteral use is 1 to 2 grams every 4 to 6 hours for 5 to 30 days depending upon the type and severity of infection. The oral dose is 500 mg to 1 gram four times daily. Common side effects include nausea, diarrhea, dyspepsia, headache, fatigue, urticaria, skin rash, renal dysfunction, liver enzyme elevations and allergic reactions. Rare potentially severe adverse events include anaphylaxis, Clostridioides difficile-associated diarrhea, and severe neutropenia.

### Hepatotoxicity

Only rare instances of clinically apparent hepatotoxicity have been linked to use of nafcillin. Typically, the injury is a cholestatic hepatitis that arises 1 to 6 weeks after starting nafcillin and can be prolonged but ultimately resolves. Rash, fever, and eosinophilia are uncommon but can occur (Case 1). The injury is much like that described with flucloxacillin and cloxacillin but is less frequent with nafcillin. Autoantibodies are uncommon. These favorable outcomes are typical but not invariable. At least one instance of acute liver failure and one with persistent cholestasis and vanishing bile duct syndrome have been reported. Interestingly, the persistent serum aminotransferase elevations that are common during high dose intravenous therapy with oxacillin appear to be rare with high doses of intravenous nafcillin. In several reports of patients who developed elevated serum aminotransferase levels while on high dose oxacillin, switching to intravenous nafcillin or other penicillin antibiotics was done without recurrence of the liver injury. This may relate to the peak doses chosen for intravenous oxacillin versus nafcillin.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The idiosyncratic hepatotoxicity that occurs with nafcillin (and other related penicillins) is sometimes but not always accompanied by signs of hypersensitivity or allergy. Yet other features suggest an immune-mediated mechanism, such as the rapid recurrence of injury with re-exposure. Too few cases of nafcillin hepatotoxicity have been reported to comment on possible HLA associations, such as the link to HLA-B*57:01 which has been made to flucloxacillin.

### Outcome and Management

The cholestatic hepatitis due to nafcillin can be symptomatic and prolonged but usually resolves, and recovery can be expected in 4 to 12 weeks. Nevertheless, instances of acute liver failure and of chronic cholestasis with vanishing bile duct syndrome have been described due to nafcillin as well as to flucloxacillin. Prednisone has been used to treat the cholestatic liver injury when it is symptomatic and prolonged, but its effects are unclear while its side effects can be serious. Patients with clinically apparent liver injury due to nafcillin should be told to avoid re-exposure to the penicillinase-resistant penicillins, including dicloxacillin and oxacillin.

Drug Class: Penicillin (Penicillinase-Resistant)

## CASE REPORT

### Case 1. Cholestatic hepatitis caused by nafcillin.(1)

An 80-year-old lady with septic arthritis was treated with intravenous nafcillin for 3 weeks and developed skin rash and diarrhea (week 2), followed by jaundice and worsening pruritus (week 3). Nafcillin was stopped, and ciprofloxacin started. She had no previous history of jaundice or risk factors for liver disease. Initial laboratory data revealed a serum bilirubin of 5.7 mg/dL, with marked elevations in alkaline phosphatase and modest elevations in serum aminotransferase levels (Table). She had eosinophilia (21%). Tests for viral hepatitis and autoantibodies were negative. Imaging the abdomen, liver and biliary tree showed no masses or evidence of obstruction. A liver biopsy was compatible with cholestatic hepatitis caused by a medication. Her recovery was slow, and she had persistent jaundice and pruritus. Prednisone (20 mg/day) was started, and she recovered clinically and biochemically over the next few weeks allowing prednisone to be discontinued after a total of 26 days.

#### Key Points

Medication: | Nafcillin
Pattern: | Cholestatic (R=0.4)
Severity: | 3+ (jaundice and hospitalization)
Latency: | Two to three weeks
Recovery: | Complete in 2 months after a course of prednisone
Other medications: | Cefazolin, possibly others

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | ALT (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
0 | | Normal | Normal | <1.0 | Nafcillin started
1 | | | Normal | <1.0
3 | 0 | | Normal | 1.5 | Nafcillin stopped
4 | 1 | | 935 | 5.7
4.5 | 1.5 | 117 | 1192 | 9.1 | Hospitalized
5 | 2 | | 1000 | 11.0
6 | 3 | | 1100 | 13.0 | Prednisone started
7 | 4 | | 350 | 3.5
8 | 5 | | 150 | 2.0 | Prednisone stopped
12 | 9 | | Normal | Normal
Normal Values | | <42 | <150 | <1.2

* Estimates made from Figure 1.

#### Comment

The abrupt onset of a cholestatic hepatitis within 3 to 4 weeks of starting nafcillin suggested that the drug was responsible. Liver biopsy confirmed intrahepatic cholestasis compatible with acute drug induced liver disease. While prednisone therapy appeared to have a beneficial effect, most cases of hepatic injury due to penicillinase-resistant penicillins follow a similar course and resolve without prednisone therapy. In this case, the dose and duration of prednisone therapy were kept to a minimum.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nafcillin – Generic

DRUG CLASS

Penicillin (Penicillinase-Resistant)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Naficillin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nafcillin | 147-52-4 | C21-H22-N2-O5-S | SID: 134975099

## CITED REFERENCES

1 Mazuryk H, Kastenberg D, Rubin R, Muñoz SJ. Cholestatic hepatitis associated with the use of nafcillin. Am J Gastroenterol 1993; 88: 1960-2.8237951

## ANNOTATED BIBLIOGRAPHY

References updated: 09 August 2026

Zimmerman HJ. Synthetic penicillins. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 596-8. (Expert review of penicillins and liver injury published in 1999).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that liver injury from the penicillins is very rare and is usually cholestatic for the oxypenicillins such as dicloxacillin and cloxacillin).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
Nahata MC, DeBolt SL, Powell DA. Adverse effects of methicillin, nafcillin and oxacillin in pediatric patients. Dev Pharmacol Ther 1982; 4: 117-23. (Prospective study of children treated with intravenous methicillin [28], nafcillin [32] or oxacillin [8]; minimal ALT elevations occurred in 1 on nafcillin and 1 on oxacillin; no jaundice). 7172968
Miller WI, Souney PF, Chang JT. Hepatic dysfunction following nafcillin and cephalothin therapy in a patient with a history of oxacillin hepatitis. Clin Pharm 1983; 2: 465-8. (Mild ALT elevations after 13 days of high dose oxacillin [18 g/day], similar increase after nafcillin and again with cephalosporin in a male injection drug user with probable chronic hepatitis C, which might have accounted for ALT fluctuations). 6627877
Lestico MR, Vick KE, Hetsko CM. Hepatic and renal dysfunction following nafcillin administration. Ann Pharmacother 1992; 26: 985-90. (Four cases of elevations in creatinine, BUN and bilirubin within 4 days of starting iv nafcillin, but most patients had abnormal liver tests before therapy; minimal change in AST and Alk P and all patients were septic and also received rifampin and/or gentamicin). 1504413
Mazuryk H, Kastenberg D, Rubin R, Muñoz SJ. Cholestatic hepatitis associated with the use of nafcillin. Am J Gastroenterol 1993; 88: 1960-2. (80-year-old developed pruritus and rash after 2 weeks of intravenous nafcillin [8 g/day], with subsequent jaundice [bilirubin rising from 5.7 to 15 mg/dL, ALT 117 U/L, Alk P 1,102 U/L]; after month of jaundice, prednisone was started with prompt improvement). 8237951
Presti ME, Janney CG, Neuschwander-Tetri BA. Nafcillin-associated hepatotoxicity. Report of a case and review of the literature. Dig Dis Sci 1996; 41: 180-4. (63-year-old developed jaundice after 5 days of intravenous nafcillin [bilirubin rising to 40 mg/dL, ALT ~210 U/L, Alk P ~375 U/L], lasting 2 months, previous history of dicloxacillin allergy-rash). 8565754
Ibáñez L, Pérez E, Vidal X, Laporte JR; Grup d'Estudi Multicènteric d'Hepatotoxicitat Aguda de Barcelona (GEMHAB). Prospective surveillance of acute serious liver disease unrelated to infectious, obstructive, or metabolic diseases: epidemiological and clinical features, and exposure to drugs. J Hepatol 2002; 37: 592-600. (Survey of 107 cases of acute serious liver disease, not due to viruses, found no instances of drug induced liver injury due to penicillinase-resistant penicillins). 12399224
Maraqa NF, Gomez MM, Rathore MH, Alvarez AM. Higher occurrence of hepatotoxicity and rash in patients treated with oxacillin, compared with those treated with nafcillin and other commonly used antimicrobials. Clin Infect Dis 2002; 34: 50-4. (Retrospective analysis of laboratory tests from 222 children receiving outpatient parenteral oxacillin, nafcillin, clindamycin or other antibiotics found 12 cases of anicteric and self-limited hepatotoxicity, 9 [22%] from oxacillin, all hepatocellular with normal bilirubin, onset in 6-43 days, resolution in 1-3 weeks; none to nafcillin; 1 clindamycin, 1 ceftriaxone and 1 ampicillin/sulbactam/gentamicin). 11731945
Sgro C, Clinard F, Ouazir K, Chanay H, Allard C, Guilleminet C, Lenoir C, Lemoine A, Hillon P. Incidence of drug-induced hepatic injuries: a French population-based study. Hepatology 2002; 36: 451-5. (A population-based study identified 34 cases of acute drug induced liver injury over a 3 year period, including 10 [25%] due to antibiotics; one was due to cloxacillin with a 5 day latency, mixed serum enzyme pattern and recovery within 2 weeks of stopping). 12143055
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Analysis of all fatal adverse drug event reports of liver injury in Sweden between 1966 and 2002, found 103 cases; most common causes were halothane [n=16], acetaminophen [14], flucloxacillin [9], and TMP-SMZ [6]). 16165719
Hussaini SH, O'Brien CS, Despott EJ, Dalton HR. Antibiotic therapy: a major cause of drug-induced jaundice in southwest England. Eur J Gastroenterol Hepatol 2007; 19: 15-20. (Review of causes of non-obstructive jaundice in 347 patients presenting between 1998 and 2004 at a single UK center, 28 were thought to be drug induced liver injury [8.1%] and antibiotics were the most common cause, 32% amoxicillin/clavulanate, 25% flucloxacillin, 18% other). 17206072
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, antimicrobials accounted for 45% of cases with 23 single agent cases due to amoxicillin/clavulanate, 13 nitrofurantoin, 10 fluoroquinolones, 9 macrolides, 9 sulfonamides, 5 cephalosporins, 3 oxacillin, 2 doxycycline, 2 amoxicillin, and one each for gentamicin, imipenem, and clindamycin, but none from dicloxacillin or nafcillin). 18955056
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12-year period at a large hospital in Bangalore, India; leading causes were antituberculosis agents [58%], anticonvulsants [11%] and NSAIDs [2%]; specific antibiotic agents included sulfamethoxazole/ trimethoprim [2%] and amoxicillin-clavulanate [1%]; no mention of 2^nd^ generation penicillins). 20648003
Ferrajolo C, Capuano A, Verhamme KMC, Schuemie M, Rossi F, Stricker BH, Sturkenboom CJM. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Among 624,673 adverse drug reports in children in a worldwide pharmacovigilance database, 6595 [1%] were for hepatic injury and antibacterials accounted for 11%, those with the highest adjusted odds ratios being aztreonam, erythromycin, ceftriaxone and minocycline; no mention of penicillins). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, but none were attributed to a penicillinase-resistant penicillin). 20949552
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection 2010; 38: 3-11. (Review of hepatotoxicity of antibiotics, mentions that cholestatic hepatitis has been reported with many beta-lactams and beta-lactamases inhibitors). 20107858
Alam MB, Kadoura A, Sathaiah M. A fatal case of nafcillin-induced hepatotoxicity: a case report and the literature review. Case Rep Med 2012; 2012: 953714. (53-year-old woman developed jaundice 15 days after starting intravenous nafcillin for osteomyelitis [bilirubin 9.6 mg/dL, ALT 24 U/L, Alk P 388 U/L], with worsening despite stopping nafcillin [bilirubin 28.7 mg/dL, ALT 24 U/L, Alk P >1884 U/L], and death from multiorgan failure 2 months later). 22844299
Monshi MM, Faulkner L, Gibson A, Jenkins RE, Farrell J, Earnshaw CJ, Alfirevic A, et al. Human leukocyte antigen (HLA)-B*57:01-restricted activation of drug-specific T cells provides the immunological basis for flucloxacillin-induced liver injury. Hepatology 2013; 57: 727-39. (T cells from persons with HLA-B*57:01 were activated when exposed to dendritic cells presenting flucloxacillin bound to albumin, and were similarly activated by oxacillin, cloxacillin and dicloxacillin). 22987284
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2-year period, including 15 due to amoxicillin/clavulanate, 1 to dicloxacillin [2nd generation] and 1 to phenoxymethylpenicillin [1st generation], the latter two cases being anicteric). 23419359
Wuillemin N, Terracciano L, Beltraminelli H, Schlapbach C, Fontana S, Krähenbühl S, Pichler WJ, et al. T cells infiltrate the liver and kill hepatocytes in HLA-B(*)57:01-associated floxacillin-induced liver injury. Am J Pathol 2014; 184: 1677-82. (Analysis of T cells from HLA-B*57:01 positive, healthy, non-flucloxacillin exposed controls demonstrated cytotoxicity of their CD8 cells by exposure to increasing concentrations of flucloxacillin with HLA-linked target cells). 24731753
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, Chirino RA, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, but none to penicillinase resistant penicillins such as oxacillin, nafcillin or dicloxacillin). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug-Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 cases [36%] were attributed to antibiotics 3 of which were due to oxacillin, all being self-limited episodes of aminotransferase elevations without jaundice; no instances of dicloxacillin or nafcillin associated liver injury). 25754159
Usui T, Naisbitt DJ. Human leukocyte antigen and idiosyncratic adverse drug reactions. Drug Metab Pharmacokinet 2017; 32: 21-30. (Review of the association of specific forms of idiosyncratic drug reactions and HLA alleles focusing on class I alleles linked with abacavir [B*57:01], allopurinol [B*58:01], carbamazepine [B*15:02], amoxicillin/clavulanate [A*02:01], and flucloxacillin [B*57:01]). 28017537
Rao Q, Schuster I, Seoud T, Zarrabi K, Goolsarran N. A patient with nafcillin-associated drug-induced liver failure. Case Rep Gastroenterol 2017; 11: 564-8. (68-year-old man with osteomyelitis developed jaundice 4 weeks after starting intravenous nafcillin, 2 g every 4 hours [bilirubin 9.4 rising to 14.1 mg/dL, ALT 127 U/L, Alk P 311 U/L, INR 1.6, eosinophils 21%], worsening for 7 days after stopping, but then resolving and 6 months later had normal liver tests). 29033779
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Bjornsson ES, Chalasani N, Fontana RJ, et al.; Drug-Induced Liver Injury Network (DILIN) investigators; International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology 2019; 156: 1707-1716.e2. (Genome-wide association studies on 2048 patients with drug induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions). 30664875
Nicoletti P, Aithal GP, Chamberlain TC, Coulthard S, Alshabeeb M, Grove JI, Andrade RJ, et al; International Drug-Induced Liver Injury Consortium (iDILIC). Drug-induced liver injury due to flucloxacillin: relevance of multiple human leukocyte antigen alleles. Clin Pharmacol Ther. 2019;106:245-253. (Among 197 patients with flucloxacillin-induced liver injury, genome wide association studies demonstrated a strong association with HLA-B*57:01 compared to controls [AF .42 vs .04], but the allele was not found increased among 6 patients with oxacillin-, dicloxacillin-. or cloxacillin-induced liver injury or in 15 with amoxicillin-induced liver injury). 30661239
Hashim A, Barnabas A, Miquel R, Agarwal K. Successful liver transplantation for drug-induced vanishing bile duct syndrome. BMJ Case Rep. 2020;13:e233052. (63-year-old woman developed jaundice 4 days after finishing a 10-day course of flucloxacillin for a skin infection [bilirubin 29.3 mg/dL, ALT 60 U/L, Alk P 287 U/L] with progressive cholestasis leading to liver transplantation 6 months after initial onset). 31948982
Timbrook TT, McKay L, Sutton JD, Spivak ES. Disproportionality analysis of safety with nafcillin and oxacillin with the FDA Adverse Event Reporting System (FAERS). Antimicrob Agents Chemother. 2020;64:e01818-19. (Analysis of the FDA’s Adverse Event Reporting System [FAERS] between 2003 and 2018 found a similar proportion of hepatotoxicity cases attributed to oxacillin [20 of 289 total adverse event reports] compared to nafcillin [18 of 331] while reports of acute renal failure were less frequent with oxacillin vs nafcillin [13 vs 52]). 31844017
Khatib S, Sabobeh T, Bock MD, Masoud A, Alallaf J. Nafcillin-induced hepatic injury: a case report and literature review. Cureus. 2021;13:e12817. (66-year-old man with toe infection developed jaundice 9 days after finishing an 18-day course of iv nafcillin [bilirubin 6.2 mg/dL, ALT 415 U/L, Alk P 506 U/L] which worsened for a few days but then gradually resolved completely without corticosteroids or other specific therapy). 33628683
Angheleanu R, Swart JN. Flucloxacillin-induced liver injury in elderly patient. BMJ Case Rep. 2021;14:e241071. (A 91-year-old woman developed dark urine, jaundice, and confusion 3 to 4 weeks after a 7- and then a 5-day course of flucloxacillin for cellulitis [bilirubin 14 mg/dL, ALT 116 U/L, Alk P 1083 U/L, INR 1.5] but ultimately improved with supportive therapy only and her condition “settled slowly” for the next 4 weeks). 33958360
Faragalla K, Lau H, Wang HL, Liu J. Cloxacillin-induced acute vanishing bile duct syndrome: a case study and literature review. Br J Clin Pharmacol. 2022;88:4633-4638. (66-year-old woman with cerebral vascular disease developed weakness and progressive jaundice a week after finishing a 6-week course of cloxacillin and sought medical care 2 weeks later [bilirubin of 44 mg/dL, ALT 877 U/L, Alk P 4279 U/L, eosinophils 1,200/μL], with persistence of jaundice and liver biopsy showing ductopenia; she was referred for liver transplant but died of complications before surgery). 35730139
Coombs S, Pittet LF, Tang K, Gwee A. Incidence and predisposing factors for flucloxacillin-related hepatotoxicity in children. J Antimicrob Chemother. 2023;78:2667-2671. (Among 393 children treated with iv flucloxacillin who had liver tests taken before and after therapy, 66 developed “hepatotoxicity” which was mostly isolated elevations in GGT, ALT, AST, or bilirubin with no serious outcomes or persistent injury). 37699070
Warring SR, Biggs JM, Morgan JA, Parbuoni KA. Comparison of adverse effect profiles of nafcillin and oxacillin in pediatric patients. J Pediatr Pharmacol Ther. 2024;29:645-649. (Among 17 children receiving iv nafcillin and 36 iv oxacillin for at least 48 hours at a single referral hospital, liver test abnormalities arose at equal rates [17%] and [18%] while creatinine elevations were less frequent with nafcillin [21% vs 30%]). 39659857
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1,739 hospitalizations for acute liver injury suspected to be due to outpatient prescribed medications none of which were attributed to a penicillinase-resistant penicillin). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database only 1 was attributed to oxacillin and none to other penicillinase-resistant penicillins: personal communication). 38992407
Huang YT, Huang YM, Lee NC, Lee PI, Ho YF. Medication hazards and outcome patterns of pediatric drug-associated liver injury in Taiwan: an analysis of 1998-2017 spontaneous adverse drug reaction reports. Drugs Real World Outcomes. 2025;12:105-114. (Among 16,673 spontaneous reports of adverse drug reactions in children made to a Taiwanese national registry between 1998 and 2017, 484 were liver related and attributed to 193 different drugs the most frequent implicated being oxacillin [25 reports] followed by methotrexate [20], phenobarbital [13], phenytoin [10] and valproate [10]; no mention of nafcillin). 39775441
Nibell O, Björk J, Nilsson A, Jacobsson G, Inghammar M. The risk of drug-induced liver injury associated with flucloxacillin: a nationwide, entropy-balanced cohort study. Clin Microbiol Infect. 2025;31:600-606. (Analysis of Swedish national registries of drug prescriptions and cases of drug induced liver disease occurring within 45 days of the prescription between 2006 and 2018 yielded rough estimates for incidence of liver injury as 1 in 525 cases per person exposed to flucloxacillin [219 cases in 1,129,091 individuals] vs 1 in 5,250 exposed to clindamycin [9 cases in 471,666]). 39716553
Perez AD, Brenner AL, Pieta E, Harrison R, Sultan S, Ponder MG, Daniels L. Incidence of acute kidney injury with the use of nafcillin versus oxacillin. Pharmacotherapy. 2026;46:e70145. (Among 171 hospitalized patients treated with nafcillin between 2020 and 2024 vs 467 with oxacillin between 2015 and 2020, acute renal injury occurred more frequently with nafcillin [33% vs 20%], in-hospital mortality was greater [13% vs 6%], and liver test elevations above 3 times ULN more common [17% vs 9%]: details of liver tests not provided). 41998805

## OTHER REFERENCE LINKS

1. Recent References on Nafcillin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=nafcillin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Nafcillin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=nafcillin)